# Bismuth

## OVERVIEW

### Introduction

Bismuth is a brittle, silvery-white metal that is used in paints, cosmetics, electronics, and a few over-the-counter pharmaceuticals, usually as bismuth subsalicylate or subcitrate, primarily to treat diarrhea and digestive disorders. Currently, the major medical use of bismuth is as a component of quadruple therapy of Helicobacter pylori infection. There is scant evidence that bismuth, even in high doses, causes serum aminotransferase elevations or clinically apparent liver injury.

### Background

Bismuth is silvery white metal similar to tin and lead that has many commercial uses and has long been used to treat indigestion and diarrhea. Bismuth is currently widely used in combination with antibiotics and omeprazole as “quadruple” therapy for eradication of Helicobacter pylori (H. pylori) infection, a major cause of peptic ulcer disease and possibly gastric carcinoma. Bismuth is found naturally as sulfide and oxide forms and is a common byproduct of lead refining. Bismuth is not an essential element and is rarely present in foods and then only in trace amounts. Nevertheless, bismuth has been used as a pharmaceutical agent typically to treat diarrhea and previously for various infections including syphilis. Currently, the major use of bismuth is in combination with at least two antibiotics and omeprazole in “quadruple” therapy for eradication of Helicobacter pylori. The mechanism of action of bismuth is not well defined, but in addition to providing a coating to ulcers and inflamed issue, bismuth has direct activity against H. pylori. Approved forms of bismuth include bismuth subcitrate potassium [140 mg] in fixed combination with metronidazole [125 mg] and tetracycline [125 mg] generically and under the brand name Pylera, and as bismuth subsalicylate [262 mg] in fixed combination with metronidazole [250 mg] and tetracycline [500 mg] generically and under the brand name Helidac. These fixed combinations were approved in doses of 2 tablets or capsules 4 times daily in combination with omeprazole (20 mg twice daily) or an H2 blocker for 10 or 14 days. Bismuth subsalicylate is also available without prescription, generically in tablets of 262 mg to combine with separate prescriptions for antibiotics and omeprazole to treat H. pylori or use as monotherapy for diarrhea and indigestion, given as 2 tablets every 30 to 60 minutes as needed but not to exceed 16 tablets in any 24 hours or to continue for more than 2 days. A popular nonprescription form of bismuth subsalicylate is “Pepto-Bismol” which is given in doses of 525 mg (30 mL) every 30 or 60 minutes until symptomatic resolution not to exceed 8 doses in one day or more than two days of therapy. Bismuth subsalicylate is rapidly disassociated in the stomach allowing salicylate to be absorbed, while bismuth is minimally absorbed. Bismuth is generally well tolerated, its major side effects being darkening of the stool and greyish discoloration of the tongue and teeth.

Bismuth toxicity has been described but is now rare. It typically presents with neurologic symptoms including change in personality, abnormal behavior, muscle twitching, myoclonal jerks, ataxia, confusion, somnolence, and stupor. Such patients have typically been taking oral tablets or solution of bismuth intermittently for months if not years, but with high doses and when given parenterally, the onset can be within days of starting bismuth. The diagnosis can be suspected based upon the neurologic symptoms and the physical finding of discoloration of the tongue and teeth. Plasma bismuth levels are high (typically above 50 μg/L with normal levels being less than 5 μg/L). After stopping bismuth, plasma levels decrease gradually accompanied by resolution of symptoms. Most patients return to baseline levels of function but in severe cases, there can be residual neurologic deficits. Excessive bismuth subsalicylate can also cause salicylism with tinnitus and weakness, but bismuth therapy is usually recommended for short periods only.

### Hepatotoxicity

In large, controlled trials of bismuth-based quadruple therapy in patients with H. pylori infection, adverse event rates were similar in patients receiving therapy that included bismuth as those on triple H. pylori regimens without bismuth. Monotherapy with bismuth for digestive complaints and diarrhea has not been linked to significant adverse events or elevations in serum ALT or bilirubin, but few studies have assessed liver tests routinely during the brief use of bismuth for episodes of diarrhea or to prevent travelers diarrhea. Further, in the many case reports of bismuth neurotoxicity, there was no mention of hepatotoxicity, and where this information was provided, liver tests were reported to be normal.

Despite the lack of evidence of liver injury in recent studies of bismuth therapy, several reports of both liver and kidney injury have been reported in the past which were attributed to bismuth. Most of these reports dealt with therapy of syphilis using injections of arsenicals and bismuth. Many of the cases were exposed to other possible hepatotoxins (arsenic), but all were reported from the 1920s and 1940s and may have been acute hepatitis B or C contracted because of inadequate sterilization of needles and syringes used in the injection therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Drug Class: Trace Elements and Metals

Other Related Drugs in the Class: Iron, Lead

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bismuth – Generic, Helidac®, Pylera®

DRUG CLASS

Trace Elements and Metals

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bismuth)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Bismuth Subsalicylate | 14882-18-9 | C7-H6-Bi-O

## ANNOTATED BIBLIOGRAPHY

References updated: 03 April 2024

Abbreviations used: H. pylori, Helicobacter pylori.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999; bismuth is not discussed).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; bismuth is not discussed).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1311-5. (Textbook of pharmacology and therapeutics).
Stokes JH, Ruedemann R, Lemon WS. Epidemic infectious jaundice and its relation to the therapy of syphilis. Arch Intern Med 1920; 26: 521-543. Not in PubMed. (Between 1916 and 1920, there were 70 cases of jaundice arising during arsphenamine therapy of syphilis at the Mayo Clinic, but the frequency increased markedly during that time [1000-fold] suggesting an epidemic of hepatitis rather than hepatitis from therapy, an idea which was also supported by a lack of uniform latency to onset after starting therapy and lack of recurrence when therapy was resumed as well as the similarity of symptoms [particularly prodromal symptoms of fever, arthritis, and rash], laboratory tests, and timing between jaundice in epidemics occurring concurrently in Minnesota).
Nomland R, Skolnik EA, McLellan LL. Jaundice from bismuth compounds used in the therapy of syphilis. JAMA 1938; 11; 19-21. Not in PubMed. (Among 75 cases of jaundice occurring during therapy of syphilis, 32 were attributed to bismuth subsalicylate, after 11 to more than 30 injections, beginning within 6 weeks of the last dose, ten having received bismuth only, the remainder also receiving arsphenamine. The authors state that the injury is indistinguishable from “catarrhal jaundice” [acute viral hepatitis] and in several cases bismuth was restarted without recurrence of jaundice, factors that suggest that the injury was due to acute hepatitis B or C transmitted by inadequately sterilized reusable syringes or needles).
Wolllmann J. Acute necrosis of the liver following sodium bismuth thioglycolate administration. Am J Syph Gonorrhea Vener Dis 1940; 29: 330-336. Not in PubMed. (Two case reports of newborns developing acute hepatic necrosis and fulminant liver failure after injections of bismuth for treatment of syphilis, one shortly after the first injection and the other after 10 injections over almost a year of therapy).
Kulchar HV, Reynolds WJ. Bismuth hepatitis. JAMA 1942; 120: 343-346. Not in PubMed. (Among 1032 inmates at San Quentin receiving treatment for syphilis between 1936 and 1942, 144 developed jaundice during bismuth therapy [typically after 4-8 of the 60 injections required]; all were male, 103 white, ages 19 to 58 years, 117 also received arsenicals).
Burns R, Thomas DW, Barron VJ. Reversible encephalopathy possibly associated with bismuth subgallate ingestion. Br Med J. 1974;1(5901):220-3. (Description of 5 patients who developed neurologic symptoms of tremulousness, confusion, ataxia, and myoclonic jerks, 6 months to 6 years after colorectal cancer surgery and long term intermittent treatment with oral bismuth subgallate; one patient died and one redeveloped symptoms upon restarting bismuth). 4818163
Lowe DJ. Adverse effects of bismuth subgallate. A further report from the Australian Drug Evaluation Committee. Med J Aust 1974; 2: 664-6. Not in PubMed. (Summary of 29 patients who developed bismuth encephalopathy between 1966 and 1972 in Australia after treatment with oral bismuth subgallate daily for a variable period [weeks to years] as a means of controlling the consistency and odor of stool in patients with ileostomy and colostomy, most resolving within 1-3 months of stopping bismuth, but some with persistent neurologic symptoms; no mention of serum aminotransferase elevations or hepatotoxicity). 4453225
Henderson IWD. Warning against products containing bismuth subsalicylate. Can Med Assoc J. 1980;123:848. (Expression of caution in using bismuth subsalicylate because of detectable levels of salicylate, which might be problematic in patients receiving anticoagulants or other salicylates). 7437988
Hasking GJ, Duggan JM. Encephalopathy from bismuth subsalicylate. Med J Aust. 1982;2:167. (60 year old man with intermittent diarrhea developed inappropriate behavior, confusion, muscle twitching, and incontinence after using bismuth subsalicylate for several years with a blood bismuth level of 72 μg/L [normal less than 5 μg/L] and who recovered completely within a month of stopping bismuth). 7132858
Bianchi Porro G, Lazzaroni M, Cortvriendt WR. Maintenance therapy with colloidal bismuth subcitrate in duodenal ulcer disease. Digestion. 1987;37 Suppl 2:47-52. (Among 39 adults with healed duodenal ulcer treated with daily bismuth subcitrate, there were mild side effects only and no patient developed bismuth encephalopathy or significant elevations in bismuth levels). 3305118
Bradley B, Singleton M, Lin Wan Po A. Bismuth toxicity--a reassessment. J Clin Pharm Ther. 1989;14:423-41. (Extensive review of the toxicity of bismuth salts, focusing upon subsalicylate and subcitrate, including melanosis, oral discoloration, skeletal problems, nephrotoxicity, hepatotoxicity, and neurotoxicity, mentions 180 published cases of liver toxicity, 140 of which were also exposed to arsphenamine and commenting that other hepatotoxins could account for all the cases reported). 2693474
Dunk AA, Prabhu U, Tobin A, O'Morain C, Mowat NA. The safety and efficacy of tripotassium dicitrato bismuthate (De-Nol) maintenance therapy in patients with duodenal ulceration. Aliment Pharmacol Ther. 1990;4:157-62. (Among 79 adults with healed duodenal ulcers treated with maintenance bismuth subcitrate [120 mg daily] for up to 12 months, therapy was well tolerated, there were no discontinuations for adverse events, and routine biochemistry tests showed no evidence of hepatotoxicity). 2104081
Jungreis AC, Schaumburg HH. Encephalopathy from abuse of bismuth subsalicylate (Pepto-Bismol). Neurology. 1993;43:1265. (67 year old woman developed tremor, confusion, and intermittent delirium, 18 months after starting use of large doses of an oral solution of bismuth subsalicylate [Pepto-Bismol] for episodes of abdominal pain, plasma bismuth was 36 μg/L six weeks after stopping bismuth, and the neurologic symptoms resolving 6 months later). 8192812
Youngman L, Harris S. BIPP madness; an iatrogenic cause of acute confusion. Age Ageing. 2004;33:406-7. (81 year old man developed acute confusion two days after nasal packing and surgery for epistaxis which was found to be attributable to bismuth toxicity, the source being bismuth iodoform paraffin paste [BIPP] used for nasal packing; serum “biochemistry” tests were reported to be normal). 15082418
Ford AC, Malfertheiner P, Giguere M, Santana J, Khan M, Moayyedi P. Adverse events with bismuth salts for Helicobacter pylori eradication: systematic review and meta-analysis. World J Gastroenterol. 2008;14:7361-70. (Systematic review of 35 controlled trials of bismuth containing regimens [for 7 to 56 days] for eradication of Helicobacter pylori in 4763 patients found no difference in overall adverse event rates, individual adverse event rates, or rates of discontinuations for adverse events; no mention of liver injury or hepatotoxicity). 19109870
Malfertheiner P, Bazzoli F, Delchier JC, Celiñski K, Giguère M, Rivière M, Mégraud F; Pylera Study Group. Helicobacter pylori eradication with a capsule containing bismuth subcitrate potassium, metronidazole, and tetracycline given with omeprazole versus clarithromycin-based triple therapy: a randomised, open-label, non-inferiority, phase 3 trial. Lancet. 2011;377(9769):905-13. Erratum in: Lancet. 2011 Nov 19;378(9805):1778. (Controlled trial of quadruple [with bismuth] vs triple therapy [omeprazole and two antibiotics] for eradication of H. pylori infection in 440 adults demonstrated superiority of the quadruple regimen [80% vs 55%], with no difference in total and serious adverse event rates and no discontinuations for liver related events; bismuth levels increased but all were well below toxic levels and fell after stopping). 21345487
Delchier JC, Malfertheiner P, Thieroff-Ekerdt R. Use of a combination formulation of bismuth, metronidazole and tetracycline with omeprazole as a rescue therapy for eradication of Helicobacter pylori. Aliment Pharmacol Ther. 2014;40:171-7. (Among 49 adults with H. pylori infection who had failed a course of triple therapy and were treated with quadruple therapy using bismuth, metronidazole, tetracycline, and omeprazole for 10 days, the eradication rate was 95% and adverse event rate 67%, but only one patient discontinued therapy early and “no clinically significant changes in laboratory tests were noted”). 24863854
Borbinha C, Serrazina F, Salavisa M, Viana-Baptista M. Bismuth encephalopathy- a rare complication of long-standing use of bismuth subsalicylate. BMC Neurol. 2019;19:212. (44 year old woman developed abnormal behavior, confusion, postural instability, and myoclonic jerks having used bismuth subsalicylate [Pepto-Bismol] irregularly for 20 years for gastrointestinal complaints [serum bismuth 260 μg/L, liver tests normal], slowing improving as serum levels of bismuth fell and was back to baseline function 3 months later; finding of greyish discoloration of teeth gradually resolving). 31464594
Silva C, Merim S, Sevivas R, Mota J, Leitão A. Bismuth subcitrate, metronidazole and tetracycline - a rare cause of drug-induced liver injury. Eur J Case Rep Intern Med. 2023;10:004119. (37 year old man with H. pylori infection developed nausea, abdominal pain, and fever 5 days after starting triple therapy with bismuth subcitrate, metronidazole and tetracycline [bilirubin 3.0 mg/dL, ALT 839 U/L, Alk P 136 U/L, INR 1.4], which resolved within 4 weeks of stopping therapy, the cause being unclear but perhaps due to metronidazole). 38077712
Moss SF, Shah SC, Tan MC, El-Serag HB. Evolving concepts in Helicobacter pylori management. Gastroenterology. 2024;166:267-283. (Review of current recommendations for management of H. pylori infection states: “retrospective studies of H. pylori eradication, although sparse, suggest that bismuth-quadruple therapy for 10-14 days is likely the current best choice for empiric therapy in the U.S.”; no mention of adverse events, ALT elevations, or hepatotoxicity). 37806461

## OTHER REFERENCE LINKS

Recent References on Bismuth: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bismuth+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Bismuth: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bismuth)